# Buspirone

## OVERVIEW

### Introduction

Buspirone is a psychoactive drug used for management of general anxiety disorders and alleviation of the symptoms of anxiety. Despite wide scale use, it is an infrequent cause of serum enzyme elevations and has not been linked to instances of clinically apparent liver injury with jaundice.

### Background

Buspirone (bue spye' rone) is an azapirone antianxiety medication that has little or no similarity to the benzodiazepines or barbiturates in its structure or mechanism of action. Buspirone appears to interact with dopamine and serotonin receptors, but its precise mechanism of action in alleviating anxiety is not known. Buspirone was approved for use in the United States in 1986. Current indications are for the treatment of generalized anxiety disorder and amelioration of the symptoms of anxiety. It has been used off label for depression (often in combination with other agents) and as treatment for substance abuse, posttraumatic stress syndrome, bruxism, tardive dyskinesia and other psychiatric and neurological conditions, but its efficacy in these situations has not been proven. Buspirone is available in tablets of 5, 10, 15 and 30 mg in several generic forms and under the brand name Buspar. Typical doses are 15 to 30 mg daily in divided doses. Side effects may include drowsiness, headache, nausea, abdominal discomfort and rash.

### Hepatotoxicity

Buspirone has been associated with infrequent serum aminotransferase elevations, but has not been linked to instances of clinically apparent liver injury in the published literature. Indeed, buspirone is often used as a control, noncytotoxic agent in assessment of other psychotropic drugs in vitro and in vivo. Buspirone is, nevertheless, metabolized in the liver by the P450 system (CYP 3A4) and has the potential of causing drug-drug interactions.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

Drug Class: Sedatives and Hypnotics, Miscellaneous

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Buspirone – Generic, Buspar®

DRUG CLASS

Sedatives and Hypnotics

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Buspirone)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Buspirone | 36505-84-7 | C21-H31-N5-O2 | Buspirone Chemical Structure

## ANNOTATED BIBLIOGRAPHY

References updated: 11 September 2017

Zimmerman HJ. Unconventional drugs. Miscellaneous drugs and diagnostic chemicals. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 731-4. (Expert review of hepatotoxicity published in 1999; buspirone is not discussed).
Larrey D, Ripault M-P. Anxiolytic agents. Hepatotoxicity of psychotropic drugs and drugs of abuse. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 455-6. (Review of hepatotoxicity of hypnotics and sedatives discusses benzodiazepines, buspirone and valerian all of which have been linked to rare cases of liver injury).
Mihic SJ, Harris RA. Hypnotics and sedatives. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 457-80. (Textbook of pharmacology and therapeutics).
Jacobson AF, Dominguez RA, Goldstein BJ, Steinbook RM. Comparison of buspirone and diazepam in generalized anxiety disorder. Pharmacotherapy 1985; 5: 290-6. (Controlled trial of buspirone vs diazepam in 66 patients with anxiety disorders found similar efficacy and fewer side effects with buspirone and "no significant differences in either groups in final laboratory assessments"). 2866493
Newton RE, Marunycz JD, Alderdice MT, Napoliello MJ. Review of the side-effect profile of buspirone. Am J Med 1986; 80 (3B): 17-21. (Analysis of side effects among 984 patients with general anxiety disorders treated with buspirone in controlled trials; side effects occurring more often with buspirone than placebo included dizziness [9% vs 2%], headache [7% vs 2%], nervousness, diarrhea, paresthesias, excitation and sweating; laboratory test results were not discussed). 2870641
Robinson D, Napoliello MJ, Schenk J. The safety and usefulness of buspirone as an anxiolytic drug in elderly versus young patients. Clin Ther 1988; 10: 740-6. (Open label postmarketing study of buspirone in 6000 patients; side effects were reported in 6-7% of patients, but no laboratory results were reported). 3219687
Feighner JP, Cohn JB. Analysis of individual symptoms in generalized anxiety--a pooled, multistudy, double-blind evaluation of buspirone. Neuropsychobiology1989; 21 (3): 124-30. (Pooled data on 427 patients with anxiety disorders treated with buspirone [10 to 60 mg daily] for 4 weeks; "the beneficial effects of buspirone were not compromised by any significant side effects"). 2615929
Rakel RE. Long-term buspirone therapy for chronic anxiety: a multicenter international study to determine safety. South Med J 1990; 83: 194-8. (Among 424 patients with chronic anxiety treated with buspirone for at least 6 months, side effects were mild to moderate in severity and "clinical laboratory tests, including hematologic and hepatic indices, revealed no clinically significant changes attributable to buspirone"). 2406933
Sheehan DV, Raj AB, Harnett-Sheehan K, Soto S, Knapp E. The relative efficacy of high-dose buspirone and alprazolam in the treatment of panic disorder: a double-blind placebo-controlled study. Acta Psychiatr Scand 1993; 88: 1-11. (Controlled trial of buspirone vs alprazolam vs placebo in 92 patients with panic disorders identified no changes in laboratory test results in buspirone treated subjects). 8372689
Sramek JJ, Frackiewicz EJ, Cutler NR. Efficacy and safety of two dosing regimens of buspirone in the treatment of outpatients with persistent anxiety. Clin Ther 1997; 19: 498-506. (Controlled trial of 2 doses of buspirone in 137 patients with anxiety disorders; common side effects were dizziness, headache, nausea, diarrhea and somnolence; there were no differences in laboratory test results in the treated patients). 9220214
Sramek JJ, Hong WW, Hamid S, Nape B, Cutler NR. Meta-analysis of the safety and tolerability of two dose regimens of buspirone in patients with persistent anxiety. Depress Anxiety 1999; 9: 131-4. (Pooled analysis of safety in studies of two doses of buspirone found no differences in laboratory tests and no mention of clinically apparent liver injury). 10356651
McRae-Clark AL, Carter RE, Killeen TK, Carpenter MJ, Wahlquist AE, Simpson SA, Brady KT. A placebo-controlled trial of buspirone for the treatment of marijuana dependence. Drug Alcohol Depend 2009; 105: 132-8. (Controlled trial of 12 weeks of buspirone vs placebo in 50 patients with marijuana dependence found no serious adverse events, but no laboratory test results reported). 19699593
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J; Drug Induced Liver Injury Network (DILIN). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology 2008; 135: 1924-34. (Among 300 cases of drug induced liver disease in the US collected from 2004 to 2008, 14 were attributed to antidepressants, including 6 to duloxetine, 3 atomoxetine, 2 fluoxetine, 2 bupropion, and 1 sertraline, but none to buspirone). 18955056
Ravindran LN, Stein MB. The pharmacologic treatment of anxiety disorders: a review of progress. J Clin Psychiatry 2010; 71: 839-54. (Review of the use of medications for anxiety disorders including tricyclic antidepressants, MAO inhibitors, SSRIs, benzodiazepines and buspirone states that buspirone has good tolerability and low potential for dependence but is of limited efficacy). 20667290
Reinhold JA, Mandos LA, Rickels K, Lohoff FW. Pharmacological treatment of generalized anxiety disorder. Expert Opin Pharmacother 2011; 12: 2457-67. (Review of pharmacological therapy of anxiety disorders, the first line agents being the SSRIs and SNRIs; buspirone has comparable but slightly weaker efficacy compared to benzodiazepines; no mention of adverse events). 21950420
Loane C, Politis M. Buspirone: what is it all about? Brain Res 2012; 1461: 111-8. (Review of efficacy and safety of buspirone and its use in other conditions such as depression, ataxia, dyskinesia and obsessive compulsive disorder; no discussion of adverse events). 22608068
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A Chirino R, et al. Profile of idiosyncratic drug induced liver injury in Latin America: an analysis of published reports. Ann Hepatol 2014; 13: 231-9. (Among 176 reports of drug induced liver injury from Latin America published between 1996 and 2012, none were attributed to buspirone). 24552865
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52.e7. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, none were attributed to buspirone or other sedative or antianxiety medications). 25754159

## OTHER REFERENCE LINKS

1. Recent References on Buspirone: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Buspirone/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Buspirone: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Buspirone)